# Teriparatide

## OVERVIEW

### Introduction

Teriparatide is a recombinant human parathyroid hormone analogue that is used to treat osteoporosis in women or men with a high risk for bone fracture. Teriparatide therapy has not been associated with serum aminotransferase elevations during therapy and has not been implicated in instances of clinically apparent liver injury.

### Background

Teriparatide (ter" i par' a tide) is a recombinant analogue of human parathyroid hormone, consisting of the first 34 amino acids of the complete 84 amino acid peptide hormone. Parathyroid hormone (PTH) has a multitude of activities, causing increase in calcium absorption from the gastrointestinal tract and increase in bone growth. Treatment with the 34 amino acid PTH analogue teriparatide (rhPTH[1-34]) has been shown to increase bone mineral density scores as assessed by DEXA scan in patients with osteoporosis, and long term therapy has been associated with a lower rate of bone fractures. Teriparatide was approved for use in the United States in 2002, and current indications are for postmenopausal women with osteoporosis at increased risk for bone fractures, for men with reduced bone mineral density due to hypogonadism, and for men or women with osteoporosis due to corticosteroid therapy. Teriparatide is available in a multi-dose pen device with 28 doses [20 µg each] for daily administration under the trade name Forteo. The recommended dose regimen is 20 µg subcutaneously once daily. Therapy for more than 2 years is not recommended. Side effects of teriparatide are uncommon, but can include injection site reactions, rash, diarrhea, nausea and vomiting and headache. Rare side effects may include local injection reactions, hypercalcemia and osteosarcoma (an association found in rats, but unproven in humans).

### Hepatotoxicity

In large clinical trials, teriparatide was not associated with changes in serum aminotransferase levels during therapy, and no cases of clinically apparent liver injury were reported. Despite availability of teriparatide for many years, there have been no published reports of clinically apparent acute liver injury attributed to its use. Thus, significant liver injury from teriparatide must be very rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Teriparatide is a recombinant polypeptide that matches the first 34 amino acids of human parathyroid hormone and, as such, is unlikely to be hepatotoxic. Polypeptide hormones are typically metabolized by the cells on or in which they act. While recombinant proteins can be metabolized by the liver, the metabolism leads largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic.

Drug Class: Osteoporosis Agents, Hormonal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Teriparatide – Forteo®

DRUG CLASS

Osteoporosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Teriparatide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Teriparatide | 52232-67-4 | C181-H291-N55-O51-S2 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 31 March 2016

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of teriparatide).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011. (Textbook on drug induced liver injury; does not discuss agents for osteoporosis).
Friedman PA. Agents affecting mineral ion homeostasis and bone turnover. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1275-1306. (Textbook of pharmacology and therapeutics).
Finkelstein JS, Klibanski A, Arnold AL, Toth TL, Hornstein MD, Neer RM. Prevention of estrogen deficiency-related bone loss with human parathyroid hormone-(1-34): a randomized controlled trial. JAMA 1998; 280: 1067-73. (Among 43 women with endometriosis receiving a gonadotrophin releasing factor [GnRH] analogue alone or in combination with teriparatide, bone mineral density decreased in those receiving GnRH alone, but increased in those given the combination; no mention of ALT elevations or hepatotoxicity). 9757854
Neer RM, Arnaud CD, Zanchetta JR, Prince R, Gaich GA, Reginster JY, Hodsman AB, et al. Effect of parathyroid hormone(1-34) on fractures and bone mineral density in postmenopausal women with osteoporosis. N Engl J Med 2001 344: 1434-41. (Among 1637 women with postmenopausal osteoporosis and vertebral fractures treated with teriparatide [20 or 40 µg daily] or placebo, new vertebral fractures were less with therapy [4%-5%] than placebo [14%]; side effects more common with teriparatide included headache, nausea, dizziness, leg cramps and mild hypercalcemia; there were no cases of osteosarcoma and no mention of ALT elevations or hepatotoxicity). 11346808
Finkelstein JS, Hayes A, Hunzelman JL, Wyland JJ, Lee H, Neer RM. The effects of parathyroid hormone, alendronate, or both in men with osteoporosis. N Engl J Med 2003; 349: 1216-26. (Among 83 men with osteoporosis treated with alendronate, teriparatide or both, increases in bone mineral density were greatest with teriparatide alone and side effects were similar, although headache, dizziness, joint pains and Alk P elevations were more frequent with teriparatide therapy; no mention of ALT elevations or hepatotoxicity). 14500805
Saag KG, Shane E, Boonen S, Marín F, Donley DW, Taylor KA, Dalsky GP, et al. Teriparatide or alendronate in glucocorticoid-induced osteoporosis. N Engl J Med 2007; 357: 2028-39. (Among 428 patients with osteoporosis attributed to corticosteroids who were treated with teriparatide or alendronate, bone density improved more with teriparatide and vertebral fractures were less often; nausea, insomnia and pharyngitis were more common with teriparatide; no mention of ALT elevations or hepatotoxicity). 18003959
Finkelstein JS, Wyland JJ, Leder BZ, Burnett-Bowie SM, Lee H, Jüppner H, Neer RM. Effects of teriparatide retreatment in osteoporotic men and women. J Clin Endocrinol Metab 2009; 94: 2495-501. (Retreatment of 21 patients with teriparatide after stopping for one year restored the losses in bone density associated with stopping treatment, but did not cause further improvement). 19401368
Drugs for postmenopausal osteoporosis. Med Lett Drugs Ther 2014; 56 (1452): 91-6. (Review of therapies for osteoporosis inlcuding parathyroid hormone which acts by stimulating bone formation rather than inhibiting bone turnover; adverse events of teriparatide can include nausea, headache, dizziness and muscle cramps; therapy has not been associated with an increased rate of osteosarcoma). 25247344
Black DM, Rosen CJ. Clinical Practice. Postmenopausal Osteoporosis. N Engl J Med 2016; 374: 254-62. (Review of the management of postmenopausal osteoporosis including use of teriparatide). 26789873

## OTHER REFERENCE LINKS

1. Recent References on Teriparatide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Teriparatide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Teriparatide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Teriparatide)